# Ropinirole

## OVERVIEW

### Introduction

Ropinirole is a selective dopamine receptor agonist used in the therapy of Parkinson disease. Ropinirole therapy is associated with low rate of transient serum enzyme elevations during treatment and has been implicated in rare cases of acute liver injury.

### Background

Ropinirole (roe pin' i role") is a synthetic, nonergot derivative dopamine receptor agonist that has selective activity for the D2 class of dopamine receptors and little agonist activity for the D1 class. For this reason, ropinirole may be better tolerated than bromocriptine or pergolide, which act on both classes of dopamine receptors. Ropinirole was approved for use in the United States in 1997 for the therapy of symptomatic Parkinson disease. Indications were later expanded to include restless legs syndrome. Ropinirole is available in tablets of 0.25, 0.50, 1, 2, 3, 4 and 5 mg under the brand name of Requip. Ropinirole is typically initiated in low doses, with adjustment upwards based upon tolerance and clinical effects. In treatment of Parkinson disease, the typical dose of ropinirole is 3 to 6 mg daily in three divided doses, often but not always in combination with levodopa/carbidopa. Ropinirole can be initiated more quickly than bromocriptine or pergolide and does not cause the profound hypotension and nausea that are typical of the ergot derivatives. Rolinirole is also approved for use in restless legs syndrome, typically starting at 0.25 mg daily, 1 to 3 hours before bedtime, and increasing the dose slowly based upon tolerance and effect. Common side effects of ropinirole include somnolence, fatigue, vivid dreams, anxiety, confusion, depression, dizziness, headache and gastrointestinal upset, symptoms that are typical of dopaminergic stimulation.

### Hepatotoxicity

Ropinirole has been reported to cause serum aminotransferase or alkaline phosphatase elevations in a small proportion of patients, but these abnormalities are usually mild, asymptomatic and self-limiting even without dose adjustment. Ropinirole has been implicated in a small number of cases of acute liver injury, but the clinical characteristics and typical pattern of enzyme elevations has not been characterized. In one case report, the time to onset was 2 months and the pattern of liver enzyme elevations was mixed and associated with marked jaundice. Immunoallergic and autoimmune features were not present. The injury resolved within 2 months of stopping. Thus, ropinirole can cause acute, clinically apparent liver injury with jaundice, but it is rare.

Likelihood score: D (possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

Ropinirole is extensively metabolized in the liver, largely by the cytochrome P450 system (CYP 1A2) to inactive metabolites. Liver injury may be caused by production of a toxic or immunogenic intermediate of its metabolism.

### Outcome and Management

Instances of liver injury attributed to ropinirole have been mild to moderate and self-limiting. No instances of acute liver failure or chronic injury have been reported.

Drug Class: Antiparkinson Agents

Other Drugs in the Subclass, Dopamine Receptor Agonists: Apomorphine, Bromocriptine, Pergolide, Pramipexole, Rotigotine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ropinirole – Generic, Requip®

DRUG CLASS

Antiparkinson Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ropinirole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ropinirole | 91374-20-8 | C16-H24-N2-O.Cl-H | Ropinirole Chemical Structure

## REFERENCES

References updated: 21 July 2017

Zimmerman HJ. Antiparkinsonism drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 715-7. (Expert review of hepatotoxicity published in 1999; among anticholinergic agents, "only trihexyphenidyl has been incriminated in hepatic injury"; other antiparkinsonism drugs discussed include levodopa, lergotrile [no longer available], pergolide and bromocriptine, but not ropinirole).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier Inc, 2013, pp. 443-62. (Review of hepatotoxicity of agents acting on the central nervous system).
Standaert DG, Roberson ED. Treatment of central nervous system degenerative disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 609-28. (Textbook of pharmacology and therapeutics).
Sethi KD, O'Brien CF, Hammerstad JP, Adler CH, Davis TL, Taylor RL, Sanchez-Ramos J, et al. Ropinirole for the treatment of early Parkinson disease: a 12-month experience. Ropinirole Study Group. Arch Neurol 1998; 55: 1211-6. (147 patients with early Parkinson disease [not on levodopa] were randomized to receive ropinirole or placebo; no mention of ALT elevations or hepatic adverse events). 9740115
Hauser RA, Molho E, Shale H, Pedder S, Dorflinger EE. A pilot evaluation of the tolerability, safety, and efficacy of tolcapone alone and in combination with oral selegiline in untreated Parkinson's disease patients. Tolcapone De Novo Study Group. Mov Disord 1998; 13: 643-7. (Among 83 patients with Parkinson disease treated with tolcapone with or without selegiline for 8 weeks, ALT elevations occurred in 1 patient [2%] on tolcapone alone). 9686768
Lambert D, Waters CH. Comparative tolerability of the newer generation antiparkinsonian agents. Drugs Aging 2000; 16: 55-65. (Review of mechanism of action, tolerability and safety of selegiline, pramipexole, ropinirole, tolcapone and entacapone in Parkinson disease). 10733264
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to agents used for Parkinson disease). 20949552
Hening WA, Allen RP, Ondo WG, Walters AS, Winkelman JW, Becker P, Bogan R, et al; SP792 Study Group. Rotigotine improves restless legs syndrome: a 6-month randomized, double-blind, placebo-controlled trial in the United States. Mov Disord 2010; 25: 1675-83. (Among 505 patients with restless leg syndrome treated with one of 4 doses of transdermal rotigotine or placebo for 6 months, symptom scores improved with higher doses [2 or 3 mg/24 hours] and side effects included application site reactions, nausea, somnolence, headache and insomnia, but there were no liver related serious adverse events). 20629075
Navacerrada F, González-Alonso MR, Alonso-Navarro H, Pilo-de-la-Fuente B, Plaza-Nieto JF, Jiménez-Jiménez FJ. Liver toxicity possibly related with ropinirole use in the treatment of restless legs syndrome. Eur J Neurol 2011; 18: e65. (68 year old woman developed jaundice 3 months after starting ropinirole for restless leg syndrome [bilirubin 11.1 mg/dL, ALT 2399 U/L, Alk P 2020 U/L], resolving within 2 months of stopping and no other cause was found). 21199184
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25,1425. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to an agent used to treat Parkinson disease). 23419359
Drugs for Parkinson's disease. Treat Guidel Med Lett 2013; 11 (135): 101-6. (Concise review of recommendations for therapy of Parkinson disease with description of mechanisms of action, efficacy and adverse events). 24165688
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an agent to treat Parkinson disease). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury from the US enrolled in a prospective database between 2004 and 2012, none were attributed to an agent used to treat Parkinson disease). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Ropinirole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Ropinirole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ropinirole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ropinirole)